# Phentermine

## OVERVIEW

### Introduction

Phentermine is a sympathomimetic amine and anorectic agent used for the short term therapy of obesity. Phentermine which has been in clinical use for more than 50 years has not been linked convincingly to either serum enzyme elevations during therapy or to instances of clinically apparent liver injury.

### Background

Phentermine (fen' ter meen) is a structural analogue to amphetamine and has similar activity in suppressing appetite, but has few of the other central nervous system effects of amphetamines and only mild abuse potential. Its effect in increasing weight loss is probably mediated by anorectic activity that is the result of enhancement of norepinephrine release in appetite centers in the brain. Phentermine was approved as a therapy for obesity in the United States in 1959 but was recommended only for short term use (less than 12 weeks) and in combination with behavioral modification, caloric restriction and exercise. Nevertheless, phentermine is widely used with more than 2 million prescriptions filled in the United States yearly. Phentermine is a Schedule IV drug, meaning that it has proven, but low abuse potential and has an accepted medical use. Phentermine is available by prescription as 30 mg tablets of phentermine base and 37.5 mg tablets of phentermine hydrochloride in multiple generic forms and under various trade names including Adipex-P, Obenix and Lonamin. The usual dose is 30 or 37.5 mg once daily. A combination of phentermine with topiramate (an anticonvulsant that has weight loss effects) has recently been approved for use for long term use in patients who are obese or are overweight and have obesity related conditions. This combination consists of fixed lower doses of phentermine and topiramate (3.75/23, 7/46, 11.25/69 and 15/92 mg) and is available in capsules under the brand name Qsymia. Common side effects of phentermine include nervousness, excitability, insomnia, headache, dry mouth, sweating, tachycardia, palpitations, nausea, constipation, and thirst. Rare severe adverse events include atrial fibrillation, acute psychosis and pulmonary hypertension.

### Hepatotoxicity

Phentermine has not been linked to an increased rate of serum enzyme elevations during therapy; however, results of ALT monitoring during phentermine therapy have rarely been reported. Despite long term availability and wide use of phentermine, there have been no published reports linking it to clinically apparent acute liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Drug Class: Weight Loss Agents, see also Phentermine-Topiramate

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Phentermine – Generic, Adipex-P®, Lonamin®

DRUG CLASS

Weight Loss Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Phentermine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Phentermine | 122-09-8 | C10-H15-N

## ANNOTATED BIBLIOGRAPHY

References updated: 06 June 2020

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 483-91. (Expert review of hepatotoxicity published in 1999; phentermine is not discussed).
Westfall TC, McArthur H, Westfall DP. Adrenergic agonists and antagonists. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 191-224. (Textbook of pharmacology and therapeutics; phentermine is listed as a sympathomimetic agent used for weight loss).
Cohen A, De Felice EA, Leb SM, Fuentes JG, Rothwell KG, Truant AP. (1968). Double-blind comparison of efficacy, safety, and side effects of Bionamin, phentermine compound, and placebo in the treatment of exogenous obesity. Curr Ther Res Clin Exp. (Controlled trial of 12 weeks of phentermine vs a combination of phentermine and amphetamine vs placebo in 120 obese prison inmates; no significant changes in serum bilirubin, ALT or Alk P in any group).
Langlois KJ, Forbes JA, Bell GW, Grant GF. (1974). A double-blind clinical evaluation of the safety and efficacy of phentermine hydrochloride (Fastin) in the treatment of exogenous obesity. Curr Ther Res Clin Exp. (Controlled trial of 16 weeks of phentermine vs placebo in 70 obese subjects; weight loss was more with phentermine [16 vs 4 pounds]; there were no differences in changes of any “safety parameters”).
Bray GA. (2000). A concise review on the therapeutics of obesity. Nutrition. (Review of drug treatment of obesity; hepatotoxicity is not discussed).
Haddock CK, Poston WS, Dill PL, Foreyt JP, Ericsson M. (2002). Pharmacotherapy for obesity: a quantitative analysis of four decades of published randomized clinical trials. Int J Obes Relat Metab Disord. (Metaanalysis of published studies of antiobesity medications; phentermine has been studied in 9 controlled trials published between 1969-92; no discussion of side effects).
Colman E. (2005). Anorectics on trial: a half century of federal regulation of prescription appetite suppressants. Ann Intern Med. (History of the approval of medications for obesity from initial agents approved in 1947 to sibutramine in 1997; phentermine was first approved in 1959, before the Kefauver-Harris amendment requiring proof of efficacy from controlled trials).
Li Z, Maglione M, Tu W, Mojica W, Arterburn D, Shugarman LR, Hilton L, et al. (2005). Meta-analysis: pharmacologic treatment of obesity. Ann Intern Med. (Systematic review of efficacy and safety of medications for obesity; phentermine therapy is associated with a significant, but modest increase in weight loss; there have been no systematic reports of adverse events, but serious adverse events were not reported in 9 controlled trials of phentermine).
Bray GA. (2005). Drug Insight: appetite suppressants. Nat Clin Pract Gastroenterol Hepatol. (Review of the mechanism of action and clinical efficacy of drugs that suppress appetite including sympathomimetic agents [amphetamine, phentermine, sibutramine], serotonin reuptake inhibitors [bupropion, fenfluramine, fluoxetine], GABAergic agents [topiramate, zonisamide], cannabinoid antagonists [rimonabant] and various peptides [leptin, neuropeptide Y, melanocortin-4]).
Ioannides-Demos LL, Proietto J, Tonkin AM, McNeil JJ. (2006). Safety of drug therapies used for weight loss and treatment of obesity. Drug Saf. (Review of safety of drug therapy of obesity; the only mention of liver adverse events was “a case of reversible hepatotoxicity associated with sibutramine”).
Kang JG, Park CY, Kang JH, Park YW, Park SW. (2010). Randomized controlled trial to investigate the effects of a newly developed formulation of phentermine diffuse-controlled release for obesity. Diabetes Obes Metab. (Randomized controlled trial of 12 weeks of phentermine vs placebo in 74 patients with obesity found no severe adverse events and no change in blood chemistry results from baseline).
(2011). Diet, drugs and surgery for weight loss. Treat Guidel Med Lett. (Concise review of approved and unapproved medical and surgical approaches to obesity; the sympathomimetic amines are the oldest weight loss drugs, but are approved for short term use only; no mention of hepatotoxicity in discussion of side effects of phentermine).
Gadde KM, Allison DB, Ryan DH, Peterson CA, Troupin B, Schwiers ML, Day WW. (2011). Effects of low-dose, controlled-release, phentermine plus topiramate combination on weight and associated comorbidities in overweight and obese adults (CONQUER): a randomised, placebo-controlled, phase 3 trial. Lancet. (Randomized controlled trial of 56 weeks of two doses of phentermine/ topiramate vs placebo in 2487 overweight or obese patients; no mention of ALT levels or hepatotoxicity).
Garvey WT, Ryan DH, Look M, Gadde KM, Allison DB, Peterson CA, Schwiers M, Day WW, Bowden CH. (2012). Two-year sustained weight loss and metabolic benefits with controlled-release phentermine/topiramate in obese and overweight adults (SEQUEL): a randomized, placebo-controlled, phase 3 extension study. Am J Clin Nutr. (Controlled extension to two years of a randomized controlled trial of phentermine/topiramate vs placebo in 676 obese patients; weight loss was sustained and common side effects were similar with longer therapy: “No dose related changes were observed in shift summaries of selected laboratory values”).
Allison DB, Gadde KM, Garvey WT, Peterson CA, Schwiers ML, Najarian T, Tam PY, Troupin B, Day WW. (2012). Controlled-release phentermine/topiramate in severely obese adults: a randomized controlled trial (EQUIP). Obesity (Silver Spring). (Randomized controlled trial of two dose regimens of phentermine/topiramate vs placebo in 1267 obese subjects; common side effects were paresthesias, dry mouth, constipation, headache, change in taste, insomnia and depression; no mention of ALT levels or hepatotoxicity).
Kang JG, Park CY. (2012). Anti-obesity drugs: a review about their effects and safety. Diabetes Metab J. (Review of the safety and efficacy of current and potentially future medications for obesity; mentions that phentermine has been available for 50 years, but there is little data on its long term efficacy and safety).
(2012). 2 new drugs for weight loss. Med Lett Drugs Ther. (Concise review of phentermine/topiramate and lorcaserin for weight loss shortly after their approval for use in the US; in discussion of side effects, no mention of hepatotoxicity).
Kim HO, Lee JA, Suh HW, Kim YS, Kim BS, Ahn ES, Roh YJ, et al. (2013). Postmarketing surveillance study of the efficacy and safety of phentermine in patients with obesity. Korean J Fam Med. (Among 795 obese Korean patients enrolled in a prospective surveillance program and treated with phentermine [37.5 mg daily], the mean weight loss at 12 weeks was 3.8 kg and 30% of patients reported adverse events, but none were serious and there was no mention of ALT elevations or hepatotoxicity).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996-2012 identified 176 cases, none of which were attributed to phentermine or other weight loss agents).
Yanovski SZ, Yanovski JA. (2014). Long-term drug treatment for obesity: a systematic and clinical review. JAMA. (Systematic review of the literature on the efficacy of long term use of drugs for obesity that were FDA approved [at the time of the analysis] mentions that phentermine, diethylpropion and phendimetrazine are approved for short term use only, but that orlistat, lorcaserin and phentermine/topiramate are approved for long term use although their efficacy is modest; no discussion of hepatotoxicity).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, one unlikely fatal case was attributed initially to phentermine).
Aagaard L, Hallgreen CE, Hansen EH. (2016). Serious adverse events reported for antiobesity medicines: postmarketing experiences from the EU adverse event reporting system EudraVigilance. Int J Obes (Lond). (Analysis of adverse event reports from antiobesity medications to the European pharmacovigilance database [EudraVigilance] between 2007 and 2013 identified 4941 reports detailing 13,957 individual adverse events, 90% serious, only 15 attributed to phentermine with 2 deaths, but none were classified as hepatobiliary).
(2018). Diet, drugs, devices, and surgery for weight management. Med Lett Drugs Ther. (Concise review of the medical and surgical therapies for obesity mentions that orlistat is modestly effective in inducing weight loss and that “severe liver injury has been reported rarely, but no cause-and-effect relationship has been established; but discussion of other weight loss agents [phentermine/topiramate, naltrexone/bupropion, lorcaserin and liraglutide] does not mention ALT elevations or hepatotoxicity).
Lewis KH, Fischer H, Ard J, Barton L, Bessesen DH, Daley MF, Desai J, et al. (2019). Safety and effectiveness of longer-term phentermine use: clinical outcomes from an Electronic Health Record Cohort. Obesity (Silver Spring). (Among 13,972 adults who initiated therapy with phentermine between 2010-15 identified by electronic health records, those who remained on long term therapy [n=144] lost an average of 7.5% of weight vs none in those on short term therapy and there were no differences in composite adverse cardiovascular outcomes with long term continuous or intermittent therapy; no mention of hepatotoxicity or ALT elevations).

## OTHER REFERENCE LINKS

1 Recent References on Phentermine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Phentermine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Phentermine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Phentermine)